# Anticholinergic Agents

## OVERVIEW

Anticholinergics are agents that decrease or block the actions of acetylcholine on its parasympathetic nervous system receptors on smooth muscle cells, glands and the central nervous system. Cholinergic receptors are usually categorized as nicotinic or muscarinic. Anticholinergics often demonstrate differential antagonism for different receptors types and subtypes, accounting in part for their variety of actions and clinical usefulness for different conditions.

The anticholinergics in clinical use include natural, semisynthetic and synthetic compounds that demonstrate a multitude of actions on smooth muscle cells and the parasympathetic nervous system. Anticholinergics have antisecretory activities and decrease nasal and bronchial secretions, salivation, lacrimation, sweating and gastric acid production, and can be used to decrease secretions in allergic and inflammatory diseases. Anticholinergics relax smooth muscle in the gastrointestinal tract, bladder and lung and can be used for gastrointestinal, urological or respiratory conditions associated with spasm and dysmotility. Some anticholinergics have antiemetic properties and are used to prevent nausea and vomiting from motion sickness or during the perioperative period. Anticholinergics increase heart rate and can be used to treat bradycardia. They are also used to reverse cholinergic overstimulation caused by cholinesterase inhibitors and neuromuscular blockers in anesthesia.

The common side effects of anticholinergic agents are largely those of parasympathetic inhibition and include dryness of the mouth and eyes, decreased sweating and hyperthermia, headache, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety, restlessness and in some instances agitation and delusions. Anticholinergics rarely cause liver injury. Their relative safety probably relates to their use in low doses for short periods of time only. Most anticholinergics are metabolized in the liver via the cytochrome P450 system.

Specific anticholinergic agents in clinical use are listed below with common brand name(s), year of approval in the United States, and major use (G=gastrointestinal, N=nausea and motion sickness, R=respiratory, U=urological). General references to the safety and hepatotoxicity of anticholinergics are given at the end of this overview section and are not repeated in the individual drug descriptions.

Anticholinergics used in Parkinson’s disease include benztropine (Cogentin: 1954), biperiden (Akineton: 1959) and trihexyphenidyl (Artane: 1949).

The natural or semisynthetic belladonna alkaloids include atropine (generic), hyoscyamine (Anaspaz: U, G) and scopolamine (Scopace, Transderm Scop: 1979, 2001, N).

The synthetic quaternary ammonium derivatives have a bulky ammonium side chain that makes them less likely to cross membranes, including the blood brain barrier, and therefore less likely to have central nervous system effects. Anticholinergic quaternary ammonium derivatives include aclidinium (Tudorza Pressair: 2012, R), clidinium (Quarzan: now withdrawn), darifenacin (Enablex: 2004, U), flavoxate (Urispas: 1970, U), glycopyrrolate (Robinul: 1961, G), ipratropium (Atrovent: 1986, R), mepenzolate (Cantil: 1956, G), methscopolamine (generic), propantheline (Pro-Banthine: 1953, G) and tiotropium (Tiova: R).

The synthetic tertiary anticholinergics include dicyclomine (Bentyl: 1996, G), fesoterodine (Toviaz: 2008, U), homatropine (generic), oxybutynin (Ditropan: 1975, U), solifenacin (VESIcare: 2004, U), tolterodine (Detrol: 1998, U), and trospium (Sanctura: 2004, U).

1. Aclidinium

2. Atropine, Homatropine

3. Benztropine

4. Biperiden

5. Darifenacin

6. Dicyclomine

7. Fesoterodine

8. Flavoxate

9. Glycopyrrolate

10. Hyoscyamine

11. Ipratropium

12. Mepenzolate

13. Methscopolamine

14. Oxybutynin

15. Propantheline

16. Revefenacin

17. Scopolamine

18. Solifenacin

19. Tiotropium

20. Tolterodine

21. Trihexyphenidyl

22. Trospium

## ANNOTATED BIBLIOGRAPHY

References updated: 18 February 2026

Zimmerman HJ. H1 Receptor antagonists. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 717-8. (Single author review of hepatotoxicity published in 1999; among anticholinergic drugs for Parkinsonism, trihexyphenidyl was suspected in two cases of acute liver failure; other anticholinergic agents are not mentioned).
Brown JH, Brandl K, Wess J. Muscarinic receptor agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's The pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 149-61. (Textbook of pharmacology and therapeutics).
Chan TY, Tang CH, Critchley JA. Poisoning due to an over-the-counter hypnotic, Sleep-Qik (hyoscine, cyproheptadine, valerian). Postgrad Med J 1995; 71: 227-8. (Among 23 patients with overdose of a combination of scopolamine, cyproheptadine and valerian, the major symptoms were drowsiness and confusion; no patient developed liver injury or ALT elevations and all recovered within 1-6 days). 7784284
Stutts JT, Washington K, Barnard JA. Cholestatic jaundice with skin desquamation in a 12-year-old girl. J Pediatr 1999; 134: 649-53. (12 year old girl developed severe rash two days after starting "Donnatal" [phenobarbital and belladonna alkaloids], with subsequent progressive cholestatic jaundice [bilirubin 5.4 rising to 28.0 mg/dL, ALT 363 U/L, Alk P 144 rising to 1743 U/L], multiorgan failure and death 90 days after presentation). 10228305
Taylor J, Kotch A, Rice K, Ghafouri M, Kurland CL, Fagan NM, Witek TJ Jr; Ipratropium Bromide HFA Study Group. Ipratropium bromide hydrofluoroalkane inhalation aerosol is safe and effective in patients with COPD. Chest 2001; 120: 1253-61. (In a controlled trial of 12 weeks of treatment with two formulations of ipratropium by inhaler vs placebo in 507 patients with COPD, side effects were similar among groups and "there were no clinically significant changes from baseline in mean laboratory values"). 11591569
Kranke P, Morin AM, Roewer N, Wulf H, Eberhart LH. The efficacy and safety of transdermal scopolamine for the prevention of postoperative nausea and vomiting: a quantitative systematic review. Anesth Analg 2002; 95: 133-43. (Systematic review of safety and efficacy of transdermal scopolamine reported most common side effects to be visual disturbances and dry mouth; no mention of hepatotoxicity). 12088957
Schlienger RG, Keller MJ, Krähenbühl S. Tolterodine-associated acute mixed liver injury. Ann Pharmacother 2002; 36 (5): 817-9. (81 year old woman developed fatigue and nausea 18 days after starting tolterodine [bilirubin 2.4 mg/dL, ALT 479 U/L, Alk P 389 U/L, eosinophils 8%], resolving within 4 weeks of stopping). 11978158
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to anticholinergic agents). 15390328
Singh-Franco D, Machado C, Tuteja S, Zapantis A. Trospium chloride for the treatment of overactive bladder with urge incontinence. Clin Ther 2005; 27: 511-30. (Systematic review of efficacy and safety of trospium found major side effects to be dry mouth, constipation and gastrointestinal upset; rare, postmarketing adverse events included Stevens Johnson syndrome, but no mention of hepatotoxicity or ALT elevations). 15978301
Zinner N, Tuttle J, Marks L. Efficacy and tolerability of darifenacin, a muscarinic M3 selective receptor antagonist (M3 SRA), compared with oxybutynin in the treatment of patients with overactive bladder. World J Urol 2005; 23: 248-52. (Trial comparing darifenacin with oxybutynin in 76 patients with overactive bladder found similar rates of response but less dry mouth with darifenacin; no mention of hepatotoxicity or ALT elevations). 16096831
Armstrong RB, Dmochowski RR, Sand PK, Macdiarmid S. Safety and tolerability of extended-release oxybutynin once daily in urinary incontinence: combined results from two phase 4 controlled clinical trials. Int Urol Nephrol 2007; 39: 1069-77. (Combined results from two trials in 1168 patients with urinary incontinence comparing oxybutynin and tolterodine found most common side effects to be gastrointestinal upset [~40%], dry mouth [~30%], constipation [~7%] and diarrhea [~7%]; no mention of hepatotoxicity or ALT elevations). 17333521
Novara G, Galfano A, Secco S, D'Elia C, Cavalleri S, Ficarra V, Artibani W. A systematic review and meta-analysis of randomized controlled trials with antimuscarinic drugs for overactive bladder. Eur Urol 2008; 54: 740-63. (Systematic review of efficacy and safety of drugs for overactive bladder including tolterodine, propiverine, solifenacin, darifenacin, fesoterodine and oxybutynin; common side effects included dry mouth and constipation; hepatotoxicity and ALT elevations were not mentioned). 18632201
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to anticholinergics). 18955056
Biastre K, Burnakis T. Trospium chloride treatment of overactive bladder. Ann Pharmacother 2009; 43: 283-95. (Review of pharmacology, metabolism, efficacy and safety of trospium; common side effects were dry mouth [22%] and constipation [9%]; no mention of hepatotoxicity or ALT elevations). 19193592
Herschorn S, Stothers L, Carlson K, Egerdie B, Gajewski JB, Pommerville P, Schulz J, et al. Tolerability of 5 mg solifenacin once daily versus 5 mg oxybutynin immediate release 3 times daily: results of the VECTOR trial. J Urol 2010; 183: 1892-8. (Among 132 patients treated with solifenacin or oxybutynin for 8 weeks, dry mouth was less common with solifenacin; hepatic side effects and ALT values were not reported). 20303119
Apfel CC, Zhang K, George E, Shi S, Jalota L, Hornuss C, Fero KE, et al. Transdermal scopolamine for the prevention of postoperative nausea and vomiting: a systematic review and meta-analysis. Clin Ther 2010; 32: 1987-2002. (Review of safety and efficacy of transdermal scopolamine; no mention of hepatotoxicity or ALT elevations). 21118734
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to anticholinergics). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but no anticholinergic was listed among the 41 most commonly implicated agents). 21039766
Shamliyan T, Wyman JF, Ramakrishnan R, Sainfort F, Kane RL. Benefits and harms of pharmacologic treatment for urinary incontinence in women: a systematic review. Ann Intern Med 2012; 156: 861-74. (Systematic review of the safety and efficacy of drugs used for urinary incontinence including fesoterodine, tolterodine, oxybutynin, solifenacin and trospium; most had modest effectiveness; hepatotoxicity was not mentioned). 22711079
Jones PW, Singh D, Bateman ED, Agusti A, Lamarca R, de Miquel G, Segarra R, et al. Efficacy and safety of twice-daily aclidinium bromide in COPD patients: The ATTAIN study. Eur Respir J 2012; 40: 830-6. (Among 828 patients with COPD treated with aclidinium by inhaler vs placebo for 24 weeks, side effects were similar among the three groups and "there were no clinically relevant changes from baseline in laboratory parameters" in any group). 22441743
Keating GM. Tiotropium bromide inhalation powder: a review of its use in the management of chronic obstructive pulmonary disease. Drugs 2012; 72: 273-300. (Review of pharmacology, efficacy and safety of tiotropium by inhaler in COPD from 30 clinical trials in 19,545 patients; while anticholinergic side effects occurred, they were uncommon; ALT elevations and clinically apparent liver injury were not mentioned). 22217233
Cardozo L, Hall T, Ryan J, Ebel Bitoun C, Kausar I, Darekar A, Wagg A. Safety and efficacy of flexible-dose fesoterodine in British subjects with overactive bladder: insights into factors associated with dose escalation. Int Urogynecol J 2012; 23: 1581-90. (Among 331 adults with overactive bladder treated with fesoterodine for 12 weeks, 30% complained of dry mouth and 9% of constipation; no mention of jaundice, ALT elevations or hepatic side effects). 22576329
Dell'utri C, Digesu GA, Bhide A, Khullar V. Fesoterodine in randomized clinical trials: an updated systematic clinical review of efficacy and safety. Int Urogynecol J 2012; 23: 1337-44. (Systematic review of the safety and efficacy of fesoterodine from 7 controlled trials of 8-12 weeks of treatment in more than 6000 patients; "No clinically relevant changes in vital signs, laboratory or electrocardiogram parameters occurred in any of the studies"). 22411206
Jara M, Wentworth C 3rd, Lanes S. A new user cohort study comparing the safety of long-acting inhaled bronchodilators in COPD. BMJ Open 2012; 2. pii: e000841. (Population based analysis of severe adverse events in patients taking tiotropium vs long acting bronchodilators for COPD found slight increase in risk of cardiovascular events with inhaled anticholinergics; no mention of liver related adverse events). 22619266
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an anticholinergic agent). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an anticholergic agent). 25754159
Drugs for overactive bladder. Med Lett Drugs Ther. 2023;65:41-45. (Concise review of drugs approved for therapy of overactive bladder in the US including anticholinergic agents [darifenacin, fesoterodine, oxbutynin, solifenacin, tolterodine and trospium] and beta-3 adrenergic receptor agonists [mirabegron and vibegron], including clinical efficacy, safety, and costs; no mention of ALT elevations or hepatotoxicity of any of the agent discussed). 36897601
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%], and atorvastatin [8%], but among drugs implicate in at least 10 cases there were no anticholinergics). 35899490
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, the most commonly implicated agents were amoxicillin-clavulanate, anti-tuberculosis agents, nitrofurantoin and diclofenac, none of the cases were attributed to an anticholinergic agent). 38992407